# Trifluridine

## OVERVIEW

### Introduction

Trifluridine/tipiracil is the combination of an antineoplastic pyrimidine analogue (trifluridine) with an inhibitor of its metabolism (tipiracil) that is used in the therapy of refractory, metastatic colorectal cancer. Trifluridine/tipiracil is associated with a low rate of transient serum enzyme elevations during therapy, but has not been implicated in cases of clinically apparent acute liver injury with jaundice.

### Background

Trifluridine (trye flure' i deen)/tipiracil (tye pir’ a sil) combines an antineoplastic pyrimidine analogue (2-deoxy-5-trifluoromethyl uridine) with a thymidine phosphorylase inhibitor that blocks its rapid metabolism, thus increasing the bioavailability of trifluridine. Trifluridine is absorbed orally and converted intracellularly to a triphosphate which becomes incorporated into DNA causing inhibition of DNA synthesis, a decrease in cellular growth and proliferation and triggering apoptosis. Trifluridine triphosphate is metabolized by thymidine phosphorylase which is inhibited by tipiracil, thus providing a longer half-life and increased intracellular concentrations of active phosphorylated trifluridine. Trifluridine/tipiracil was shown to have potent activity in vitro in cellular and in vivo in animal models of colon cancer. In clinical trials, this combination led to prolongation of progression-free as well as overall survival in patients with previously treated, refractory metastatic colorectal cancer. Trifluridine/tipiracil was approved for use in the United States in 2015 and is available in tablets of 15 mg/14 mg and 20 mg/19 mg under the commercial name Lonsurf. Current indications are for refractory, metastatic colorectal cancer after previous treatment with other agents. The recommended dose regimen is 35 mg/m^2^ (based upon the trifluridine component) orally twice daily on days 1 through 5 and days 8 through 12 of each 28-day cycle. Common side effects include bone marrow suppression, weakness, fatigue, nausea, anorexia, diarrhea, abdominal pain and fever. Less common, but potentially severe adverse events include severe myelosuppression, febrile neutropenia, infections, sepsis and embryo-fetal toxicity.

### Hepatotoxicity

Pooled analyses of preregistration clinical trials reported that serum enzyme elevations occurred in up to 24% of patients on trifluridine/tipiracil therapy, but were also elevated in 27% of controls. Similarly, ALT values above 5 times ULN occurred in 2% of trifluridine/tipiracil treated compared to 4% of placebo treated subjects. In these and subsequent studies, clinically apparent liver adverse reactions attributed to trifluridine/tipiracil were not reported.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Hepatotoxicity from trifluridine/tipiracil appears to be rare and liver test abnormalities are most likely to be due to the underlying condition rather than the drug itself. Trifluridine is metabolized in most cells by thymidine phosphorylase to 5-trilfuorosmethyluracil, which is inactive. Tipiracil is excreted largely unchanged in the urine. Neither agent appears to affect hepatic cytochrome P450 activities.

### Outcome and Management

The serum aminotransferase and alkaline phosphatase elevations that occur during trifluridine/tipiracil therapy are usually transient, asymptomatic and mild. Trifluridine/tipiracil has not been linked to cases of acute liver failure, chronic hepatitis or vanishing bile duct syndrome. There is no information on cross sensitivity to hepatic injury between trifluridine/tipiracil and other pyrimidine analogues used in cancer chemotherapy such as capecitabine, gemcitabine and fluorouracil.

Drug Class: Antineoplastic Agents

Other Drugs in the Subclass, Pyrimidine Analogues: Azacitidine, Capecitabine, Cytarabine, Decitabine, Floxuridine, Fluorouracil, Gemcitabine

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Trifluridine/Tipiracil – Lonsurf®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Trifluridine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Trifluridine | 70-00-8 | C10-H11-F3-N2-O5 | Trifluridine Chemical Structure
Tipiracil | 183204-74-2 | C9-H11-Cl-N4-O2 | Tipiracil Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 16 April 2017

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999 before the availability of trifluridine/tipiracil).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3nd ed. Amsterdam: Elsevier, 2013, p. 541-67. (Review of hepatotoxicity of cancer chemotherapeutic agents; trifluridine/tipiracil is not discussed).
Chabner BA, Barnes J, Neal J, Olson E, Mujagic H, Sequist L, Wilson W, Longo DL, Mitsiades C, Richardson P. Cytotoxic agents. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1677-1730. (Textbook of pharmacology and therapeutics).
Yoshino T, Mizunuma N, Yamazaki K, Nishina T, Komatsu Y, Baba H, Tsuji A, et al. TAS-102 monotherapy for pretreated metastatic colorectal cancer: a double-blind, randomised, placebo-controlled phase 2 trial. Lancet Oncol 2012; 13: 993-1001. (Among 169 Japanese patients with refractory, metastatic colorectal cancer treated with trifluridine/tipiracil or placebo, overall survival was improved [9.0 vs 6.6 months], but serious adverse events were more frequent with trifluridine [19% vs 9%]; no mention of ALT elevations or hepatotoxicity). 22951287
Mayer RJ, Van Cutsem E, Falcone A, Yoshino T, Garcia-Carbonero R, Mizunuma N, Yamazaki K, et al.; RECOURSE Study Group. Randomized trial of TAS-102 for refractory metastatic colorectal cancer. N Engl J Med 2015; 372: 1909-19. (Among 800 patients with refractory, metastatic colorectal cancer treated with trifluridine/tipiracil or placebo, overall survival was improved [7.3 vs 5.5 months] and adverse events more frequent with trifluridine included nausea, vomiting, anorexia, fatigue, diarrhea and fever, while ALT elevations occurred in 24% on trifluridine vs 22% on placebo and were above 5 times ULN in 2% vs 4%). 25970050
In brief: trifluridine/tipiracil (Lonsurf) for metastatic colorectal cancer. Med Lett Drugs Ther 2016; 58 (1496): e77. (Concise review of the mechanism of action, clinical efficacy, safety and costs of trifluridine/tipiracil shortly after its approval for use in the US; mentions common side effects, but not ALT elevations or hepatotoxicity). 27249100
Kotani D, Shitara K, Kawazoe A, Fukuoka S, Kuboki Y, Bando H, Okamoto W, et al. Safety and Efficacy of trifluridine/tipiracil monotherapy in clinical practice for patients with metastatic colorectal cancer: experience at a single institution. Clin Colorectal Cancer 2016; 15: e109-15. (Among 55 patients with refractory, metastatic colorectal cancer treated with trifluridine/tipiracil, common severe adverse events included neutropenia and infection; no mention of ALT elevations or hepatotoxicity). 26723516
Sueda T, Sakai D, Kudo T, Sugiura T, Takahashi H, Haraguchi N, Nishimura J, et al. Efficacy and safety of regorafenib or TAS-102 in patients with metastatic colorectal cancer refractory to standard therapies. Anticancer Res 2016; 36: 4299-306. (In a retrospective analysis of patients with metastatic colorectal cancer treated with regorafenib [n=23] or trifluridine/tipiracil [n=14], survival rates were similar [5.8 vs 6.3 months], but adverse events were more frequent with regorafenib including hepatotoxicity [52% vs 7%]). 27466548
Burness CB, Duggan ST. Trifluridine/tipiracil: a review in metastatic colorectal cancer. Drugs 2016; 76 (14): 1393-402. (Review of the pharmacology, clinical efficacy and safety of trifluridine/tipiracil as therapy of metastatic colorectal cancer; mentions that the rates of total as well as serious adverse events were similar in trifluridine- as in placebo-treated subjects; no mention of ALT elevations or hepatotoxicity). 27568360

## OTHER REFERENCE LINKS

1. Recent References on Trifluridine/Tipiracil: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Trifluridine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Trifluridine/Tipiracil: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Trifluridine)